# Valacyclovir

## OVERVIEW

### Introduction

Valacyclovir is a nucleoside analogue antiviral agent and prodrug of acyclovir which is used in therapy of herpes simplex and varicella-zoster virus infections. Valacyclovir has been associated with rare instances mild, clinically apparent liver injury.

### Background

Valacyclovir (val" ay sye' kloe vir), which is sometimes spelled valaciclovir, is an acyclic purine nucleoside analogue, the L-valyl ester prodrug of acyclovir that once absorbed, is rapidly converted to acyclovir, its active moiety. Valacyclovir has greater oral bioavailability than acyclovir and has similar activity against herpes viruses, including herpes simplex 1 and 2, cytomegalovirus, Epstein-Barr virus and varicella-zoster. Once converted to acyclovir, the drug is phosphorylated intracellularly by viral kinases. The resultant triphosphate competes with guanosine for incorporation into viral DNA, blocking viral DNA polymerase activity. Because its activation requires the presence of viral kinases, valacyclovir is only activated in virally infected cells. Valacyclovir is indicated for therapy of mucocutaneous and genital herpes simplex infections, both type 1 and 2 and for herpes zoster. Valacyclovir was approved for use in the United States in 1995 and is widely used in the treatment and prophylaxis of genital and mucocutaneous herpes simplex infection. Valacyclovir is available as capsules of 500 mg and 1000 mg generically and under the brand name of Valtrex. The usually recommended dose in adults is 500 to 1000 mg once or twice daily. Side effects are uncommon, but include headache, dizziness and gastrointestinal upset. Rare but potentially severe adverse events include renal dysfunction, CNS effects and severe thrombocytopenia.

### Hepatotoxicity

Oral therapy with valacyclovir is associated with a low rate of mild-to-moderate serum aminotransferase elevations, but these abnormalities are usually asymptomatic and self-limited even with continuation of therapy. Complicating the attribution of liver test abnormalities to valacyclovir therapy is the fact that enzyme elevations are not uncommon during the course of varicella-zoster infection (both chickenpox and shingles) and can progress to clinically apparent hepatitis and even acute liver failure. Clinically apparent liver disease due to valacyclovir itself is rare, but isolated reports have been published. The time to onset was short (1 to 2 weeks) and the course mild, with few symptoms and rapid resolution (Case 1). The pattern of liver injury described was mixed hepatocellular-cholestatic. Immunoallergic features and autoantibodies were absent.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

After absorption, valacyclovir is converted to acyclovir by the liver, which is metabolized intracellularly in viral infected cells and is excreted largely unchanged by the kidneys. Valacyclovir is not activated in cells without viral kinases, perhaps accounting for the absence or rarity of hepatic injury.

### Outcome and Management

No instances of acute liver failure or chronic liver injury have been linked to valacyclovir use. The liver injury associated with valacyclovir is usually mild and resolves rapidly. There is no information on possible cross sensitivity of hepatic injury among the various nucleoside analogues used to treat herpes virus infections, but valacyclovir is a prodrug of acyclovir which is its active moiety.

Drug Class: Antiviral Agents

Other Antiviral Agents for Herpes Virus Infections: Acyclovir, Cidofovir, Famciclovir, Foscarnet, Ganciclovir, Letermovir, Valganciclovir

## CASE REPORT

### Case 1. Mild acute hepatitis with jaundice after valacyclovir therapy.(1)

A 71 year old woman with shingles was treated with valacyclovir (3 g daily) for 7 days and developed abdominal and back pains by the end of therapy, leading to hospitalization 2 days later. She was also taking acetaminophen for pain in doses up to 3 g daily. She had no history of liver disease, risk factors for hepatitis or alcohol abuse. She was taking thyroid hormone for hypothyroidism, but no other medications. She had a history of cholecystectomy. On admission, she did not have fever or rash and the abdominal pain was attributed to back strain. Laboratory tests showed elevations in serum ALT and alkaline phosphatase with mild hyperbilirubinemia (Table), but no elevations in serum amylase or creatinine. Valacyclovir was stopped. Tests for hepatitis A, B and C were negative as were autoantibodies. An ultrasound showed a prominent common bile duct (9 mm), but subsequent ERCP did not show obstruction or biliary stones. After 5 days, acetaminophen was stopped and other analgesics were substituted. Two weeks after initial presentation, the liver test abnormalities had resolved.

#### Key Points

Medication: | Valacyclovir (3 g daily)
Pattern: | Mixed (R=3.5)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 1 week
Recovery: | Complete in 2 weeks
Other medications: | Acetaminophen, thyroid hormone

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
9 days | 2 days | 376 | 246 | 3.3 | Admission: abdominal pain
11 days | 4 days | 181
13 days | 6 days | 33 | 296 | 0.6
14 days | 7 days | 27 | 219
18 days | 11 days | 46 | 243 | 0.6
3 weeks | 2 weeks | 8 | 78
Normal Values | | <60 | <130 | <1.2

#### Comment

A mild case of liver injury with a mixed pattern of serum enzyme elevations arising by the end of a one-week course of valacyclovir. While she was also taking acetaminophen in somewhat high doses, the pattern of enzyme elevations and absence of renal dysfunction were atypical for acetaminophen toxicity. The possibility of varicella-zoster induced hepatitis should also be considered.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Valacyclovir – Generic, Valtrex®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Valacyclovir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Valacyclovir | 124832-26-4 | C13-H20-N6-O4

## CITED REFERENCE

1 Renkes P, Trechot P, Blain H. (1999). Valaciclovir-induced hepatitis. Acta Clin Belg.

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2020

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; valacyclovir is not discussed, but acyclovir is said to have not caused "overt hepatic injury").
Núñez M. Herpesviridae treatment. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 512-3. (Review of hepatotoxicity of antiviral agents; mentions that valacyclovir has been associated with serum enzyme elevations during oral therapy).
Acosta EP. Antiviral agents(nonretroviral). In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1105-18. (Textbook of pharmacology and therapeutics).
Bodsworth NJ, Crooks RJ, Borelli S, Vejlsgaard G, Paavonen J, Worm A-M, Uexkull N, et al., International Valaciclovir HSV Study Group. (1997). Genitourin Med. (Among 999 patients randomized at 48 sites to treatment with acyclovir or valacyclovir for 5 days for recurrent HSV infection, there was equivalent efficacy and "no clinically important changes from screening in any clinical chemistry variable").
Dits H, Frans E, Wilmer A, Van Ranst M, Fevery J, Bobbaers H. (1998). Varicella-zoster virus infection associated with acute liver failure. Clin Infect Dis. (30 year old previously healthy man exposed to a child with chicken pox developed fever, vesicular rash and progressive liver disease [bilirubin 0.82 mg/dL, ALT 27 rising to 1650 U/L, Alk P not given, INR 1.02 rising to 10.44], with multiorgan failure and death, culture of liver showing varicella zoster virus).
Renkes P, Trechot P, Blain H. (1999). Valaciclovir-induced hepatitis. Acta Clin Belg. (71 year old woman with shingles developed abdominal pain 7 days after starting valacyclovir and acetaminophen [3 g/day] with ALT 376 U/L, Alk P 246 U/L and bilirubin 3.3 mg/dL, resolving within 2 weeks of stopping: Case 1).
Ormrod D, Scott LJ, Perrry CM. (2000). Valaciclovir: a review of its long term utility in the management of genital herpes simplex virus and cytomegalovirus infections. Drugs. (Review of efficacy and safety of long term valacyclovir use; rates of side effects are similar in frequency to those in patients on acyclovir and on placebo; a single case of hepatitis due to valacyclovir has been reported in abstract form).
Mantadakis E, Anagnostatou N, Danilatou V, Markaki EA, Spanaki AM, Briassoulis G, Kalmanti M. (2005). Fulminant hepatitis due to varicella zoster virus in a girl with acute lymphoblastic leukemia in remission: report of a case and review. J Pediatr Hematol Oncol. (4 year old girl on dexamethasone while in remission from acute leukemia developed abdominal pain followed by worsening liver tests and progressive liver failure [bilirubin 0.9 rising to 2.6 mg/dL, ALT 3790 U/L, INR 2.68 rising to 4.38], autopsy showing massive liver necrosis and varicella zoster virus).
Brantley JS, Hicks L, Sra K, Tyring SK. (2006). Valacyclovir for the treatment of genital herpes. Expert Rev Anti Infect Ther. (Review of chemistry, pharmacology, efficacy and safety of valacyclovir in treating genital herpes; side effect profile is similar to acyclovir with no significant drug interactions; no mention of ALT elevations or hepatotoxicity).
(2007). Drugs for non-HIV viral infections. Treat Guidel Med Lett. (Review of status of non-antiretroviral antiviral agents for prevention and treatment of herpes, varicella-zoster, cytomegalovirus, influenza A and B, and hepatitis B and C; no mention of liver related side effects for valacyclovir).
Breuer J, Whitley R. (2007). Varicella zoster virus: natural history and current therapies of varicella and herpes zoster. Herpes. (Review of use of antiviral agents in herpes virus infections).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 8 were attributed to antiviral agents including one due to valacyclovir; 50 year old woman with shingles developed jaundice 10 days after stopping a 2 week course of valacyclovir [peak bilirubin 6.4 mg/dL, ALT 785 U/L, Alk P 666 U/L]).
Mizoguchi F, Nakamura S, Iwai H, Kubota T, Miyasaka N. (2008). Varicella-zoster virus hepatitis in polymyositis. Mod Rheumatol. (31 year old woman with polymyositis on prednisolone and methotrexate developed fever, pustular rash and hepatitis [bilirubin not given, ALT 230 rising to 4795 U/L], resolving with acyclovir, prednisolone and plasmapheresis therapy).
Drebber U, Preuss SF, Kasper HU, Wieland U, Dienes HP. (2008). Postoperative fulminant varicella zoster virus hepatitis with fatal outcome: a case report. Z Gastroenterol. (49 year old man with laryngeal cancer developed liver injury 15 days after laryngectomy [bilirubin and Alk P not given, ALT 1332 U/L], with progressive hepatic failure and death; autopsy showing coagulative necrosis and viral inclusions in adjacent hepatocytes, typical of varicella zoster hepatitis).
Al-Hamoudi WK. (2009). Severe autoimmune hepatitis triggered by varicella zoster infection. World J Gastroenterol. (23 year old man developed jaundice within a month and while recovering from chicken pox [bilirubin 24.8 mg/dL, ALT 1066 U/L, Alk P 185 U/L, IgG 2050 mg/dL, ANA negative], responding to prednisone, but with relapses when drug was stopped or dose reduced).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 4 of which were due to antiretroviral agents, but none were attributed to an antiherpes virus agent).
(2013). Antiviral drugs. Treat Guidel Med Lett. (Review of safety and efficacy of valacyclovir treatment and prophylaxis against varicella and herpes zoster infections; mentions that it is converted to acyclovir and its side effects are likely to be similar; does not specifically mention liver injury).
Prado NMBL, Messias GC, Santos GO, Nunes VS, Schinonni MI, Paraná R. (2019). Prospective monitoring of drug use: drug-induced liver injury in a primary healthcare center. Arq Gastroenterol. (Among 149 patients followed in a primary care center in Brazil, three were suspected to have developed liver injury due to a medication including nimesulide, budesonide and valacyclovir marked by moderate elevations in ALT levels [176-182 U/L], normal Alk P [46-52 U/L], normal bilirubin [0.3-0.4 mg/dL] and no symptoms, and resolving rapidly on drug discontinuation).
Burton MJ, Penman A, Sunesara I, McGuire BM, Hook EW. (2014). A pilot study examining the safety and tolerability of valacyclovir in veterans with hepatitis C virus/herpes simplex virus type 2 coinfection. Am J Med Sci. (Among 30 patients with chronic hepatitis C and herpes simplex 2 infection treated with valacyclovir [1 g] or placebo twice times daily for 8 weeks followed by a washout period and then cross over to the alternative therapy, there was no toxicity and ALT levels declined slightly [-8% to -10%] as did HCV RNA levels [- 24%] during valacyclovir therapy).
(2018). Antiviral drugs for varicella-zoster virus and herpes simplex virus infections. Med Lett Drugs Ther. (Concise review of the therapy of varicella-zoster and herpes simplex infections, mentions that valacyclovir is a pro-drug of acyclovir and has similar efficacy and side effects but better absorption and pharmacokinetics; common adverse event include gastrointestinal disturbances, headache, malaise; no mention of ALT elevations or hepatotoxicity).
Kennedy PGE, Gershon AA. (2018). Clinical features of varicella-zoster virus infection. Viruses. (Review of the clinical features of varicella-zoster infections, including chicken pox and herpes zoster [reactivation] mentions that hepatitis can accompany varicella-zoster infections).

## OTHER REFERENCE LINKS

1 Recent References on Valacyclovir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Valacyclovir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Valacyclovir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Valacyclovir)